# Psoralen

## OVERVIEW

### Introduction

8-methoxsalen and 5-methoxsalen are furocoumarins referred to collectively as psoralens that have photosensitizing activity and are used orally and topically in conjunction with ultraviolet irradiation for the therapy of psoriasis and vitiligo. Psoralens have been linked to a low rate of transient serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Psoralen (sor’ a len) is a natural furocoumarin found in the seeds of Psoralea corylifolia and other botanicals and used for their photosensitizing activity in the therapy of psoriasis and vitiligo. Psoralen is actively taken up by epidermal cells and intercalates into DNA. Upon exposure to ultraviolet (UV) light, psoralen forms cross links between DNA causing cell injury and death. The most commonly used form of psoralen, known as 8-methoxsalen (meth ox’ a len) or 8-methoxypsoralen, has been available in the United States since the 1950s and was typically administered orally or topically as an ointment with ultraviolet light treatment. 8-methoxsalen with ultraviolet radiation (PUVA) was approved for use in refractory psoriasis in the United States in 1982. Its current indications are limited to severe, recalcitrant and disabling psoriasis. It also has been used to treat vitiligo and cutaneous T cell lymphoma. Psoralen is now not commonly used, largely because of concerns over the long term safety of ultraviolet light therapy and the availability of newer, more effective and better tolerated agents for psoriasis. 8-methoxsalen is available in 10 mg capsules for oral use and as lotions of 1% methoxsalen for topical administration generically and under the brand name Oxsoralen. The typical oral dose is adjusted by weight and ranges from 10 to 70 mg, 2 to 4 times weekly taken 1 to 2 hours before a controlled dose of ultraviolet irradiation. Common side effects include nausea, headache, dizziness, fatigue, depression and erythematous and pruritic skin reactions to UV light. Rare, but potentially severe adverse reactions include increased risk of basal cell carcinoma and melanoma.

### Hepatotoxicity

In open label trials, serum ALT or AST elevations occurred in 2% to 12% of subjects treated with methoxsalen and UV light. The elevations were usually mild-to-moderate in severity, asymptomatic and self-limited in course. Clinically apparent acute liver injury has also been reported with oral methoxsalen therapy, but only in isolated case reports including one instance attributed to topical methoxsalen therapy. The time to onset has ranged from 1 to 5 months, the typical latency being 6 to 8 weeks. The onset is generally insidious, with appearance of nausea and abdominal pain followed by jaundice. Fever occurs in some cases, but rash and eosinophilia are not common. The typical pattern of injury is hepatocellular. Most published cases of psoralen hepatotoxicity have been mild-to-moderate in severity, but severe jaundice and death from hepatic failure has been described in patients with preexisting cirrhosis who developed further acute liver injury attributed to methoxsalen. Most cases resolve within 6 to 8 weeks.

Psoralen is also present in many herbal products used to treat various conditions including psoriasis and vitiligo. Case reports of acute liver injury have been reported with the use of seeds, powder and teas prepared from Psoralea corylifolia under various Chinese names such as Boh Gol Zhee, Xin Cu Hei Su and Qu Bai Ba Bu Gi Pian. Chemical analyses have shown the presence of psoralen in these products. The clinical features of these cases have resembled those attributed to methoxsalen with a latency of 1 to 2 months, a hepatocellular pattern of injury, absence of immunoallergic or autoimmune features, and self-limited course with recovery within 6 to 8 weeks.

Likelihood score: C (probable rare cause of clinically apparent liver injury)

### Mechanism of Injury

The mechanism of possible liver injury due to psoralen is unknown. Psoralen is metabolized in the liver, and the liver injury may be due to a rare intermediate of its metabolism. In some cases, hypersensitivity may play a role.

### Outcome and Management

While most cases of acute liver injury due to psoralen have been mild-to-moderate in severity and self-limited in course, fatal instances have been reported in patients with preexisting liver disease. Several instances of rapid recurrence of injury with rechallenge have been reported and rechallenge should be avoided.

Drug Class: Dermatologic Agents, Psoriasis Agents

## CASE REPORTS

### Case 1. Acute hepatitis due to methoxypsoralen.(1)

A 55 year old woman with widespread psoriasis who had failed to respond to acitretin, ultraviolet (UV) light and triamcinolone cream developed nausea, abdominal pain and fatigue after 40 treatments with 5-methoxypsoralen. Methoxypsoralen was started in a dose of 20 mg and raised to 40 mg given orally three times weekly just before each UV light treatment. She had a history of a previous episode of jaundice 6 years previously that was attributed to flucloxacillin. She had no other major medical illnesses, had no risk factors for viral hepatitis and was taking no other medications or herbal preparations. Acitretin had been stopped 10 weeks before presentation and her liver tests had been normal before starting antipsoriasis therapy. Physical examination showed an improvement in her psoriatic lesions and mild jaundice. She had no fever, new onset rash or lymphadenopathy. Laboratory tests showed a total serum bilirubin of 3.2 mg/dL, ALT 2727 U/L, AST 1444 U/L and GGT 857 U/L. The white blood cell eosinophil count was normal. Tests for hepatitis A, B and C were negative as were routine autoantibodies (ANA, AMA). The methoxypsoralen and UV light treatment were discontinued. She worsened for a few days, serum bilirubin rising to 8.8 mg/dL. Thereafter, the abnormalities began to resolve and all tests were near normal 7 weeks after presentation (Table).

#### Key Points

Medication: | 5-methoxypsoralen (40 mg three times weekly; 40 courses)
Pattern: | Hepatocellular-mixed (R=5.1)
Severity: | 3+(jaundice and hospitalization)
Latency: | ~3 months
Recovery: | ~2 months
Other medications: | Triamcinolone cream

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 22 | 65 | 0.4 | Diagnosis of psoriasis
Pre | | 27 | 54 | 0.2 | Acitretin started
3 months | -2 days | 2727 | 857 | 3.2 | Nausea, abdominal pain
| 9 days | 2438 | 714 | 8.8
4 months | 18 days | 1750 | 646 | 5.4
5 months | 52 days | 95 | 202 | 0.7
Normal Values | | <40 | <65 | <1.2

#### Comment

This woman with refractory psoriasis had a good clinical response to photochemical therapy using 5-methoxypsoralen (also known as methoxsalen) and narrow beam UV light, but developed constitutional symptoms followed by jaundice after approximately 3 months of therapy. The pattern of serum enzyme elevations was mixed, with prominent increases in serum aminotransferase as well as GGT levels (alkaline phosphatase was not reported, so that the calculation of the R value had to use GGT instead which yielded a value in the low "hepatocellular" range). Recovery was slow, but there was no evidence of hepatic failure. Most cases of psoralen induced liver injury have had a similar latency of 1 to 4 months and a hepatocellular pattern of injury, with no immunoallergic or autoimmune features.

### Case 2. Acute hepatitis due to herbal agent containing psoralen.(2)

A 44 year old Korean woman developed nausea and fatigue 4 weeks after starting an herbal agent called "Boh-Gol-Zhee", followed by jaundice 3 weeks later. She was taking the preparation for menopausal symptoms and ingested it with a cup of black tea "every 1 hour for 7 weeks". Physical examination showed jaundice, but no fever, rash or enlargement of the liver or spleen. Laboratory tests showed a total serum bilirubin of 7.3 mg/dL (direct 4.2 mg/dL), ALT 398 U/L, AST 774 U/L, alkaline phosphatase 367 U/L and GGT 192 U/L. Tests for hepatitis A, B and C were negative as were routine autoantibodies (ANA, SMA, anti-LKM). Ultrasonography showed an abnormal liver texture, but no evidence of obstruction. Liver biopsy showed severe hepatitis with confluent necrosis. The herbal preparation was stopped and she was admitted for observation for ten days. She improved without specific therapy and in follow up 4 months later, all liver tests were normal.

#### Key Points

Medication: | Boh Gol Zhee (dried Psoralea corylifolia seeds)
Pattern: | Mixed (R~3.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | ~1-2 months
Recovery: | Within 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
4 weeks | 0 | | | | Nausea and fatigue
7 weeks | 0 | 398 | 367 | 7.3 | Jaundice
| 6 days | 263 | | | Liver biopsy
8 weeks | 9 days | 185 | | 5.2 | Discharged
16 weeks | 2 months | 31 | | Normal
Normal Values | | Not given | <1.2

#### Comment

Boh-Gol-Zhee is the Korean name for the herbal product prepared from dried mature seeds of Psoralea corylifolia, which is used predominantly to treat menopausal symptoms. The seeds have more than 35 identified chemical constituents including psoralen, psoralidin, backuchiol, bavachin, genistein (a phytoestorgen), various resins and fatty oils. Powdered extracts of P. corylifolia have been linked to several instances of jaundice, and psoralen has been considered the most likely culprit in causing liver injury. The cases of liver injury from herbal sources of psoralen have resembled those attributed to methoxsalen treatment of psoriasis and vitiligo.

### Case 3. Acute liver failure attributed to methoxsalen therapy.(3)

A 54 year old man with cirrhosis due to long term methotrexate therapy of psoriasis developed jaundice and evidence of hepatic failure a few weeks after starting 8-methoxsalen with UV irradiation. He had progressive weakness, nausea, abdominal pain, confusion, ascites and peripheral edema. He was transferred to a liver transplant center where laboratory test results showed a total serum bilirubin of 39.6 mg/dL (direct 16.8 mg/dL), ALT 83 U/L, AST 144 U/L, alkaline phosphatase 114 U/L and GGT 20 U/L. The prothrombin time was 23 seconds and serum albumin 2.7 g/dL. Tests for hepatitis B, CMV, EBV and HSV were negative. Emergency liver transplantation was done 3 days after transfer and the explant showed cirrhosis, sinusoidal fibrosis, acute hepatocellular necrosis and collapse, and marked cholestasis. He recovered and was discharged 6 weeks later and was active and working when the report was published 6 years later.

#### Key Points

Medication: | 8-methoxypsoralen (dose not given)
Pattern: | Acute on chronic liver failure
Severity: | 5+ (liver failure, transplantation)
Latency: | ~4 weeks (not clearly stated)
Recovery: | None
Other medications: | None mentioned, methotrexate previously for 15 years

#### Comment

A 54 year old man with well compensated cirrhosis attributed to long term methotrexate therapy of psoriasis developed acute hepatic decompensation after being started on therapy with methoxsalen and ultraviolet light. The latency to onset of symptoms and jaundice was not clearly defined in the report and pretreatment laboratory values were not provided. Drug induced liver injury superimposed upon chronic liver disease or cirrhosis often has a different pattern of clinical presentation, usually defined as "acute-on-chronic". Laboratory values may also be unusual, the only change from baseline abnormalities being a sudden appearance of jaundice followed rapidly by signs and symptoms of hepatitis failure. It remains unclear whether drug induced liver injury is more severe in patients with preexisting liver disease or if the injury is just less well tolerated. The two published instances of hepatic failure due to psoralen hepatotoxicity occurred in patients with known, preexisting cirrhosis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

8-Methoxsalen – Generic, Oxsoralen®

DRUG CLASS

Dermatologic Agents, Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=8-Methoxsalen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
8-Methoxsalen | 298-81-7 | C12-H8-O4

## CITED REFRENCES

1 Stephens RB, Cooper A. Hepatitis from 5-methoxypsoralen occurring in a patient with previous flucloxacillin hepatitis. Australas J Dermatol 1999; 40: 217-9. 10570561
2 Nam SW, Baek JT, Lee DS, Kang SB, Ahn BM, Chung KW. A case of acute cholestatic hepatitis associated with the seeds of Psoralea corylifolia (Boh-Gol-Zhee). Clin Toxicol (Phila) 2005; 43: 589-91. 16255343
3 Markin RS, Donovan JP, Shaw BW Jr, Zetterman RK. Fulminant hepatic failure after methotrexate and PUVA therapy for psoriasis. J Clin Gastroenterol 1993; 17: 311-3. 8308218

## ANNOTATED BIBLIOGRAPHY

References updated: 16 January 2020

Abbrevations used: UV, ultraviolet.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity published in 1999 mentions that methoxsalen has been associated with both hepatocellular and cholestatic injury, which can be fatal).
Sewell MJ, Burkhart C, Morrell D, Goldsmith L. Dermatological pharmacology. In, Brunton LL, Chabner BA, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
Fitzpatrick TB, Imbrie JD, Labby D. Effect of methoxsalen on liver function. JAMA 1958; 167: 1586-9. 13563146 (Among 24 normal volunteers given methoxsalen or placebo for 3 months, serial determinations of liver function tests, including thymol and zinc turbidity, cephalin-flocculations and BSP excretion, remained normal in all).
Tucker HA. Clinical and laboratory tolerance studies in volunteers given oral methoxsalen. J Invest Dermatol 1959; 32: 277-80. 13641797 (Among 100 healthy male volunteers given methoxsalen and 20 given placebo for 21 days, none developed hepatic function test abnormalities [bilirubin, thymol and zinc turbidity and cephalin-flocculation]).
Parrish JA, Fitzpatrick TB, Tanenbaum L, Pathak MA. Photochemotherapy of psoriasis with oral methoxsalen and long-wave ultraviolet light. N Engl J Med 1974; 291: 1207-11. 4422691 (Among 21 patients with psoriasis treated with oral methoxsalen and long wave ultraviolet (UV) phototherapy for an unstated amount of time, all had improvement in skin lesions and serum bilirubin, and AST and Alk P remained normal in all).
Swanbeck G, Thyresson-Hök, Bredberg A, Lambert B. Treatment of psoriasis with oral psoralens and longwave ultraviolet light. Therapeutic results and cytogenetic hazards. Acta Derm Venereol 1975; 55: 367-76. 52973 (Among 40 patients with psoriasis treated with 8-methoxypsoralen and UV phototherapy, 6 had transient elevations in serum aminotransferase levels, but further specifics were not given).
Dahl KB, Brodthagen H. [Psoriasis vulgaris. Treatment with carbon-arc light baths and 8-methoxypsoralen. A double-blind investigation]. Ugeskr Laeger 1976; 138: 2221-4. Danish. 788271 (Among 31 patients with psoriasis treated with 8-methoxsalen and UV phototherapy, all except one had a clinical response, but 4 [13%] developed transient ALT elevations, 3 seemingly precipitated by alcohol ingestion).
Weismann K, Howitz J, Bro-Jorgensen A. [Treatment of psoriasis with 8-methoxypsoralen and long-wave ultraviolet light]. Ugeskr Laeger 1976 138: 2225-8. Danish. 968972 (Among 73 patients with psoriasis treated with 8-methoxsalen or placebo followed by UV phototherapy for an average of 6 weeks, 40% had side effects of nausea, dyspepsia and vertigo, and 2 [3%] had transient AST elevations that resolved with stopping).
Melski JW, Tanenbaum L, Parrish JA, Fitzpatrick TB, Bleich HL. Oral methoxsalen photochemotherapy for the treatment of psoriasis: a cooperative clinical trial. J Invest Dermatol 1977; 68: 328-35. 864273 (Among 1308 patients with psoriasis treated with oral methoxsalen and UV phototherapy for up to 18 months, psoriasis cleared in 88% and side effects were uncommon and generally mild; serum bilirubin, AST and Alk P levels remained normal or decreased).
Bjellerup M, Bruze M, Hanssen A, Krook G, Ljunggren JB. Liver injury following administration of 8-methoxypsoralen during PUVA therapy. Acta Derm Venereol (Stockh) 1979; 59: 371-2. 92158 (57 year old woman with psoriasis developed symptoms 7 weeks after starting 8-methoxsalen and UV phototherapy 4 times weekly [bilirubin normal, ALT 368 U/L, Alk P normal], resolving within 7 weeks with two positive rechallenges [ALT ~ 2 times ULN]).
Pariser DM, Wyles RJ. Toxic hepatitis from oral methoxsalen phototherapy(PUVA). J Am Acad Dermatol 1980; 3: 248-50. 7451691 (59 year old woman with psoriasis resistant to methotrexate developed fatigue and fever 5 hours after starting a 14th course of 8-methoxsalen and UV phototherapy [bilirubin 1.4 mg/dL, AST 103 rising to 775 U/L, Alk P 100 U/L], resolving in 3 days and recurring with oral, but not topical reexposure).
Chretien P, Galmiche JP, Payeeneville JM, Fouin-Fortunet H, Lauret P, Boismare F, Colin R. Effects of oral methoxy-psoralen photochemotherapy(PUVA) on liver function and antipyrin kinetics. Int J Clin Pharmacol Res 1983; 3: 343-7. 6678827 (Among 19 patients with psoriasis treated with methoxsalen and UV phototherapy for 28 days, liver tests remained normal, but antipyrine clearance decreased, likely because of CYP 450 interactions).
Freeman K, Warin AP. Deterioration of liver function during PUVA therapy. Photodermatol Photoimmunol Photomed 1984; 1: 147-8. 6527958 (57 year old man with psoriasis and alcoholic liver disease developed jaundice 8 weeks after starting oral methoxsalen and UV phototherapy, with progressive liver failure and death; autopsy showing cirrhosis and alcoholic hepatitis).
Nyfors A, Dahl-Nyfors B, Hopwood D. Liver biopsies from patients with psoriasis related to photochemotherapy(PUVA): findings before and after 1 year of therapy in twelve patients. A blind study and review of literature on hepatotoxicity of PUVA. J Am Acad Dermatol 1986; 14(1): 43-8. 3950113 (Among 12 patients with psoriasis treated with psoralen and UV phototherapy [average 79 treatments], liver biopsies done before and after a year of treatment showed no change in any light microscopic finding).
Hann SK, Park YK, Im S, Koo SW, Haam IB. The effect on liver transaminases of photoxic drugs used in systemic photochemotherapy. J Am Acad Derm 1992; 26: 646-8. 1597556 (Among 162 patients with psoriasis or vitiligo treated with various forms of psoralen and UV phototherapy, only 3 [2%] developed ALT elevations [peak values 44, 52 and 275], all without symptoms or jaundice, resolving rapidly).
Markin RS, Donovan JP, Shaw BW Jr, Zetterman RK. Fulminant hepatic failure after methotrexate and PUVA therapy for psoriasis. J Clin Gastroenterol 1993; 17: 311-3. 8308218 (54 year old man with psoriasis and cirrhosis after long term methotrexate developed jaundice within a few weeks of starting oral 8-methoxsalen and UV phototherapy, with progression to liver failure [bilirubin 39.6 mg/dL, ALT 83 U/L, Alk P 114 U/L] and undergoing urgent liver transplant, the explant showing cirrhosis and acute necrosis with collapse).
Perharic L, Shaw D, Colbridge M, House I, Leon C, Murray V. Toxicological problems resulting from exposure to traditional remedies and food supplements. Drug Saf 1994; 11: 284-94. 7848547 (Retrospective and prospective survey identified 1070 enquiries following exposure to herbal products, including 4 cases of liver from Chinese herbs, one case of which was attributed to psoralea coryliflora, no details given).
Park YM, Kim TY, Kim CW. Reproducible elevation of liver transaminases by topic 8-methoxypsoralen. Photodermatol Photoimmunol Photomed 1994; 10: 261-3. 7727284 (17 year old woman with vitiligo developed jaundice and pruritus 3 months after starting topical 8-methoxsalen and UV phototherapy [bilirubin 7.6 mg/dL, ALT 1150 U/L, Alk P 554 U/L], resolving within 4 months of stopping and recurring upon reexposure to psoralen alone without UV light UV phototherapy).
Berg M, Ros AM. Treatment of psoriasis with psoralens and ultraviolet A. A double-blind comparison of 8-methoxypsoralen and 5-methoxypsoralen. Photodermatol Photoimmunol Photomed 1994; 10: 217-20. 7880762 (Among 38 patients with psoriasis treated with either 5- or 8-methoxsalen and UV phototherapy, efficacy was similar as were side effects; one patient developed liver injury 3 weeks after starting 5-methoxsalen [ALT 1500 U/L, bilirubin and Alk P not provided], which returned to normal between 6 months and one year after stopping).
Choi HJ, Kim S, Hann SK, Park YK. (1995). The effect on liver transaminases of 5-methoxypsoralen used in systemic photochemotherapy. Ann Dermatol. (Among 80 patients with psoriasis or vitiligo treated with 5-methoxsalen and UV phototherapy, 4 had ALT elevations [59, 59, 235, 266 U/L] after 3.5-14 months of therapy, resolving within 2 months of stopping; no mention of jaundice or symptoms).
McNeely W, Goa KL. 5-methoxypsoralen: a review of its effects in psoriasis and vitiligo. Drugs 1998 56: 667-90. 9806110 (Review of chemistry, mechanism of action, pharmacology, efficacy and safety of 5-methoxypsoralen states that side effects are lower with 5- compared to 8-methoxypasoralen, the most common being gastrointestinal upset, skin redness and pruritus; mild to moderate ALT elevations occurred in 5% of patients in one study [Choi 1995]).
Stephens RB, Cooper A. Hepatitis from 5-methoxypsoralen occurring in a patient with previous flucloxacillin hepatitis. Australas J Dermatol 1999; 40: 217-9. 10570561 (55 year old woman with psoriasis developed nausea and abdominal pain 5 months after starting 5-methoxypsoralen [bilirubin 3.2 mg/dL, ALT 2727 U/L, GGT 857 U/L], resolving within 2 months of stopping).
Nam SW, Baek JT, Lee DS, Kang SB, Ahn BM, Chung KW. A case of acute cholestatic hepatitis associated with the seeds of Psoralea corylifolia (Boh-Gol-Zhee). Clin Toxicol (Phila) 2005; 43: 589-91. 16255343 (44 year old woman developed jaundice 7 weeks after starting daily ingestion of Psoralea corylifolia tea "every hour" [bilirubin 7.3 mg/dL, ALT 398 U/L, Alk P 367 U/L], with rapid improvement on stopping).
Cheung WI, Tse ML, Ngan T, Lin J, Lee WSK, Poon WT, Mak TWL, et al. Liver injury associated with the use of Fructus Psoraleae(Bol-gol-zhee or Bu-gu-zhi) and its related proprietary medicine. Clin Toxicol 2009; 47: 683-5. 19640237 (3 cases of liver injury after use of dried seeds of P. corylifolia to treat skin conditions, including 2 men and 1 woman, ages 20-39 years, taking product for 2-8 weeks, developing jaundice [bilirubin 5.1-5.5 mg/dL, ALT 720-2248 U/L, Alk P 115-177 U/L, INR 1.1-1.2], resolving within 4-9 weeks of stopping; analysis of the products [each with a different name] revealed psoralen, isopsoralen and bakuchiol).
Menter A, Korman NJ, Elmets CA, Feldman SR, Gelfand JM, Gordon KB, Gottlieb A, et al. Guidelines of care for the management of psoriasis and psoriatic arthritis: Section 5. Guidelines of care for the treatment of psoriasis with phototherapy and photochemotherapy. J Am Acad Dermatol 2010; 62: 114-35. 19811850 (Guidelines on use of phototherapy in psoriasis by the American Academy of Dermatology mentions acute common toxicities of erythema, pruritus, serosis, pigmentation and gastrointestinal symptoms and potential long term toxicities of squamous cell carcinoma and melanoma, but does not mention ALT elevations or hepatotoxicity).
Walker D, Jacobe H. Phototherapy in the age of biologics. Semin Cutan Med Surg 2011; 30: 190-8. 22123416 (Discussion of role of psoralen and UV phototherapy in psoriasis and other skin conditions in view of availability of newer biologic agents, concluding that phototherapy is a valuable option; ordered October 12, 2014).
Almutawa F, Alnomair N, Wang Y, Hamzavi I, Lim HW. Systematic review of UV-based therapy for psoriasis. Am J Clin Dermatol 2013; 14: 87-109. 23572293 (Systematic review of safety and efficacy of UV based therapy of psoriasis discusses erythema and tolerability, but does not mention hepatotoxicity or ALT elevations).
Carrascosa JM, Plana A, Ferrándiz C. Effectiveness and safety of psoralen-UVA (PUVA) topical therapy in palmoplantar psoriasis: a report on 48 patients. Actas Dermosifiliogr 2013; 104: 418-25. 23680012 (Among 48 patients with palmoplantar psoriasis treated with psoralen and UV A phototherapy, beneficial responses occurred in 63% and side effects in 25%; ALT and hepatotoxicity were not reported).
Bansal S, Sahoo B, Garg V. Psoralen-narrowband UVB phototherapy for the treatment of vitiligo in comparison to narrowband UVB alone. Photodermatol Photoimmunol Photomed 2013; 29: 311-7. 24118425 (Among 45 Indian patients with vitiligo treated with narrowband UV B phototherapy with or without psoralen, response rates were better in those receiving psoralen, but adverse events were also more common, including nausea; no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. 24552865 (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to psoralen).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to psoralen).
El-Mofty M, Rasheed H, El-Eishy N, Hegazy RA, Hafez V, Shaker O, El-Samanoudy SI. A clinical and immunological study of phototoxic regimen of ultraviolet A for treatment of alopecia areata: a randomized controlled clinical trial. J Dermatolog Treat 2019; 30: 582-7. 30411986 (Among 40 patients with alopecia areata treated with topical psoralen and UV A phototherapy vs intralesional injections of corticosteroids, response rates [hair regrowth] were similar in both groups, whereas adverse events were more frequent with psoralen including itching and local erythemia; ALT elevations and hepatotoxicity were not mentioned).
Drugs for psoriasis. Med Lett Drugs Ther 2019; 61(1574): 89-96. 31381544 (Concise review of current recommendations on drug therapy of psoriasis mentions that UV A phototherapy can be used for widespread disease and addition of topical or oral psoralen with UV phototherapy is also effective but may increase the risk of skin cancer; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Psoralen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Psoralen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Psoralen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Psoralen)